# Budesonide

## OVERVIEW

### Introduction

Budesonide is a corticosteroid that undergoes high first pass elimination by the liver so that systemic levels after oral administration are minimal. Budesonide has been used orally for several immune mediated gastrointestinal and liver diseases and as nasal spray or by inhalation for allergic rhinitis, asthma and chronic obstructive lung disease. Neither inhalant nor oral budesonide has been linked to serum enzyme elevations during therapy or to convincing instances of clinically apparent acute liver injury.

### Background

Budesonide (bue des' oh nide) is a synthetic corticosteroid that has a high first pass elimination by the liver (~90%) so that after oral administration systemic exposure is minimal. Budesonide has been used to replace conventional corticosteroids given by inhalant or orally. Budesonide nasal spray and inhalants have been used to treat allergic rhinitis, asthma and bronchospasm occurring in patients with chronic obstructive pulmonary disease. Budesonide tablets have been used to replace conventional corticosteroids as the therapy of gastrointestinal immune mediated diseases such as ulcerative colitis, Crohn disease, collagenous colitis and autoimmune hepatitis. In many of these situations, oral budesonide was found to be equivalent to oral prednisone in efficacy, but better tolerated because of a reduction in glucocorticoid side effects. Budesonide was approved for use initially in 1996 as a nasal spray and solution for inhalation. In 2001, oral budesonide was approved as therapy for inflammatory bowel disease. Currently, budesonide is available for oral administration as capsules of 3 mg generically and under the brand names Entocort EC and Uceris (among others). The recommended dose is 9 mg daily. Current indications are limited to mild-to-moderate forms of ulcerative colitis and Crohn disease. Oral budesonide has also been evaluated as therapy of autoimmune hepatitis and collagenous colitis with reports of benefit, but has not been officially approved for these uses. Budesonide is also available as nasal sprays and solution for inhalation in many formulations generically and under brand names such as Pulmicort, Rhinocort and Symbicort. Approved indications for the inhalation forms of budesonide include allergic rhinitis, asthma and chronic obstructive pulmonary disease with an asthmatic component. Side effects of budesonide are not common and most are reported to be similar in rate with placebo or comparator therapies. The typical corticosteroid adverse events of weight gain, moon facies, buffalo hump, worsening of glaucoma, cataracts, osteopenia and others are not common with budesonide therapy and the majority of patients treated have no or only mild evidence of adrenal suppression.

### Hepatotoxicity

Long term therapy with budesonide has not been linked to elevations in serum enzyme levels, and in clinical trials rates of ALT elevations were similar with budesonide as with placebo treatment. In controlled trials, there were no reported cases of clinically apparent liver injury associated with its use. Unlike conventional systemically administered corticosteroids, budesonide has not been linked to episodes of reactivation of hepatitis B. Budesonide has been used in severe autoimmune liver diseases without evidence that it causes worsening of liver injury. Because it can improve serum aminotransferase elevations in patients with autoimmune hepatitis, its withdrawal may be followed by rebound elevations as also occurs with conventional corticosteroid therapy. In addition, there has been a single case report of acute serum aminotransferase elevations during budesonide therapy that resolved when the drug was stopped, but documentation was limited and the patient was on multiple other potentially hepatotoxic drugs.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which budesonide might cause serum aminotransferase elevations or liver injury is not known. Glucocorticoids can cause liver injury, but generally only when given in high systemic doses, unlikely to be achieved by oral budesonide.

Drug Class: Hormones, Corticosteroids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Budesonide – Generic, Entocort®, Uceris®

DRUG CLASS

Corticosteroids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Budesonide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Budesonide | 51333-22-3 | C25-H34-O6
Prednisolone | 50-24-8 | C21-H28-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 30 October 2020

Abbreviations: IBD, inflammatory bowel disease; COPD, chronic obstructive pulmonary disease; LABA, long-acting beta_2_ agonists; LAMA, long-acting muscarinic antagonists.

Zimmerman HJ. Corticosteroids. Drugs to treat rheumatic/musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 541. (Textbook of hepatotoxicity published in 1999; discusses conventional corticosteroids, but does not mention budesonide).
Chitturi S, Farrell GC. Corticosteroids. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 613-4. (Review of liver injury from corticosteroids; mentions hepatic steatosis and acute liver injury following high doses of corticosteroids [usually methylprednisolone], but does not discuss budesonide).
Schimmer BP, Funder JW. Adrenocortical steroids: ACTH, adrenal steroids, and pharmacology of the adrenal cortex. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1215-333. (Textbook of pharmacology and therapeutics).
(1994). Intranasal budesonide for allergic rhinitis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of budesonide shortly after its approval in the US as an intranasal formulation to treat allergic rhinitis; no mention of hepatotoxicity or ALT elevations).
Greenberg GR, Feagan BG, Martin F, Sutherland LR, Thomson AB, Williams CN, Nilsson LG, et al. (1996). Oral budesonide as maintenance treatment for Crohn's disease: a placebo-controlled, dose-ranging study. Canadian Inflammatory Bowel Disease Study Group. Gastroenterology. (Among 105 patients with Crohn disease treated with budesonide [3 or 6 mg daily] or placebo for 1 year, there were delays in onset of relapse in patients receiving budesonide, but rates of relapse at 1 year were the same in all groups and glucocorticoid side effects were higher with budesonide).
Campieri M, Ferguson A, Doe W, Persson T, Nilsson LG. (1997). Oral budesonide is as effective as oral prednisolone in active Crohn's disease. The Global Budesonide Study Group. Gut. (Among 178 patients with Crohn disease treated with budesonide [9 mg daily or 4.5 mg twice daily] or prednisolone [40 mg daily] for 12 weeks, clinical remissions occurred in 60% of patients receiving prednisolone or budesonide once daily, but in only 42% on budesonide twice daily; while side effects except for moon face were similar in all groups, no mention of ALT elevations or hepatotoxicity).
Ferguson A, Campieri M, Doe W, Persson T, Nygård G. (1998). Oral budesonide as maintenance therapy in Crohn's disease--results of a 12-month study. Global Budesonide Study Group. Aliment Pharmacol Ther. (Among 75 patients with Crohn disease in clinical remission treated with oral budesonide [3 or 6 mg] or placebo daily for 12 months, relapse rates were similar [48% and 46% vs 60%] while rates of glucocorticoid side effects were somewhat higher [23% and 46% vs 15%]; no mention of ALT elevations or hepatotoxicity).
Leuschner M, Maier KP, Schlichting J, Strahl S, Herrmann G, Dahm HH, Ackermann H, et al. (1999). Oral budesonide and ursodeoxycholic acid for treatment of primary biliary cirrhosis: results of a prospective double-blind trial. Gastroenterology. (Among 20 patients with primary biliary cirrhosis treated with ursodiol and either budesonide or placebo for up to two years, improvements in serum enzymes and liver histology were greater in those receiving budesonide, but bone density deteriorated more).
Czaja AJ, Lindor KD. (2000). Failure of budesonide in a pilot study of treatment-dependent autoimmune hepatitis. Gastroenterology. (Among 10 patients with autoimmune hepatitis dependent upon prednisone therapy to maintain remission, only 3 could be maintained on budesonide, the other seven requiring conversion back to prednisone; exacerbations of liver disease were attributed to glucocorticoid withdrawal rather than hepatotoxicity of budesonide).
Angulo P, Batts KP, Jorgensen RA, LaRusso NA, Lindor KD. (2000). Oral budesonide in the treatment of primary sclerosing cholangitis. Am J Gastroenterol. (Among 21 patients with sclerosing cholangitis treated with oral budesonide [9 mg daily] for 12 months, there were slight but nonsignificant decreases in Alk P and AST levels, but no changes in liver histology and appearance of glucocorticoid side effects in several patients and marked loss of bone mass as assessed by DEXA scanning).
van Hoogstraten HJ, Vleggaar FP, Boland GJ, van Steenbergen W, Griffioen P, Hop WC, van Hattum J, et al. (2000). Budesonide or prednisone in combination with ursodeoxycholic acid in primary sclerosing cholangitis: a randomized double-blind pilot study. Belgian-Dutch PSC Study Group. Am J Gastroenterol. (Among 18 patients with sclerosing cholangitis on ursodiol who were treated with budesonide [3 or 9 mg] or prednisone [10 mg] daily for 8 weeks, neither symptoms nor liver tests improved with budesonide therapy, while side effects were considered transient and minor except in one patient who developed autoimmune hepatitis requiring prednisone therapy during withdrawal of budesonide treatment).
Angulo P, Jorgensen RA, Keach JC, Dickson ER, Smith C, Lindor KD. (2000). Oral budesonide in the treatment of patients with primary biliary cirrhosis with a suboptimal response to ursodeoxycholic acid. Hepatology. (Among 22 patients with primary biliary cirrhosis and an incomplete response to ursodiol who were treated with budesonide [9 mg daily] for 1 year, there were marginal improvements in Alk P, but continued progression of disease and worsening bone density and 2 patients developed glucocorticoid side effects; no worsening of serum enzyme levels during therapy).
(2001). Nebulized budesonide for asthma in children. Med Lett Drugs Ther. (Concise review of the clinical efficacy, adverse events and costs of nebulized budesonide shortly after its approval for use in children with asthma in the US; no mention of ALT elevations or hepatotoxicity).
Budesonide (Entocort EC) for Crohn's disease. (2002). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, adverse events and costs of oral budesonide shortly after its approval for use in Crohn disease in the US; mentions that glucocorticoid side effects are less with budesonide than prednisone, but still occur as does suppressive effects on adrenal function; no mention of hepatotoxicity).
Sagir A, Wettstein M, Oette M, Erhardt A, Häussinger D. (2002). Budesonide-induced acute hepatitis in an HIV-positive patient with ritonavir as a co-medication. AIDS. (A 48 year old man with chronic HIV infection and rectal cancer developed marked ALT elevations [peak 1010 U/L; bilirubin and Alk P not given] 19 days after starting 5-ASA and budesonide for radiation colitis, which resolved after stopping budesonide and did not recur with restarting anti-HIV medications and 5-ASA; liver biopsy showed no necrosis or inflammation).
Escher JC, European Collaborative Research Group on Budesonide in Paediatric IBD. (2004). Budesonide versus prednisolone for the treatment of active Crohn's disease in children: a randomized, double-blind, controlled, multicentre trial. Eur J Gastroenterol Hepatol. (Among 48 children with Crohn disease treated with budesonide or prednisolone, clinical remissions at week 8 occurred in similar rates [55% vs 71%] in both groups, but corticosteroid side effects [moon faces, acne] and adrenal suppression were less with budesonide).
Sandborn WJ, Löfberg R, Feagan BG, Hanauer SB, Campieri M, Greenberg GR. (2005). Budesonide for maintenance of remission in patients with Crohn's disease in medically induced remission: a predetermined pooled analysis of four randomized, double-blind, placebo-controlled trials. Am J Gastroenterol. (Combined analysis of 380 patients with Crohn disease participating in 4 clinical trials of maintenance of remission with budesonide [3 or 6 mg daily] vs placebo found median time to relapse was longer with 6 mg of budesonide [268 days] than 3 mg [170 days] or placebo [154 days], while adverse events included easy bruising in 5-10%, acne in 5-10% and moon face in 3-4%).
Rautiainen H, Kärkkäinen P, Karvonen AL, Nurmi H, Pikkarainen P, Nuutinen H, Färkkilä M. (2005). Budesonide combined with UDCA to improve liver histology in primary biliary cirrhosis: a three-year randomized trial. Hepatology. (Among 77 patients with primary biliary cirrhosis treated with budesonide and ursodiol or ursodiol alone for 3 years, serum enzymes improved in both groups, while liver fibrosis improved slightly with the combination but worsened with ursodiol alone; 8 patients reported glucocorticoid side effects which led to early discontinuation in one).
Miehlke S, Madisch A, Bethke B, Morgner A, Kuhlisch E, Henker C, Vogel G, et al. (2008). Oral budesonide for maintenance treatment of collagenous colitis: a randomized, double-blind, placebo-controlled trial. Gastroenterology. (Among 77 patients with primary biliary cirrhosis treated with ursodiol and budesonide vs ursodiol alone for 3 years, liver histology improved more frequently with the combination while serum Alk P and ALT levels improved in both groups).
(2008). Budesonide/formoterol (Symbicort) for asthma. Med Lett Drugs Ther. (Concise summary of the efficacy, safety, drug interactions and costs of the inhalant combination of budesonide and formoterol shortly after its approval in the US for asthma; side effects were mostly local but some glucocorticoid side effects occurred; no mention of ALT elevations or hepatotoxicity).
Bonderup OK, Hansen JB, Teglbjaerg PS, Christensen LA, Fallingborg JF. (2009). Long-term budesonide treatment of collagenous colitis: a randomised, double-blind, placebo-controlled trial. Gut. (Among 46 patients who achieved a clinical remission in collagenous colitis on oral budesonide [9 mg daily for 6 weeks], the relapse rate was 65% among 23 who stopped therapy compared to only 26% who remained on 6 mg daily of budesonide; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
Manns MP, Woynarowski M, Kreisel W, Lurie Y, Rust C, Zuckerman E, Bahr MJ, et al., European AIH-BUC-Study Group. (2010). Budesonide induces remission more effectively than prednisone in a controlled trial of patients with autoimmune hepatitis. Gastroenterology. (Among 207 patients with newly diagnosed autoimmune hepatitis treated with budesonide [6 or 9 mg daily] or prednisone [40 mg initially], complete responses were more frequent with budesonide than prednisone [47% vs 18%], and glucocorticoid side effects were less [52% vs 72%]; no mention of hepatotoxicity).
(2010). Safety of inhaled corticosteroids in chronic obstructive pulmonary disease (COPD). Med Lett Drugs Ther. (Concise review of the safety and efficacy of two combinations of corticosteroids and beta-2 agonists in chronic obstructive pulmonary disease; mentions that inhaled corticosteroids may be associated with an increased risk of pneumonia and oral candidiasis; no mention of ALT elevations or hepatotoxicity).
(2013). Budesonide (Uceris) for ulcerative colitis. Med Lett Drugs Ther. (Concise review of the efficacy, adverse effects, drug interactions and costs of oral budesonide shortly after its approval for use in ulcerative colitis in the US; does not mention liver related side effects).
Woynarowski M, Nemeth A, Baruch Y, Koletzko S, Melter M, Rodeck B, Strassburg CP, et al., European Autoimmune Hepatitis-Budesonide Study Group. (2013). Budesonide versus prednisone with azathioprine for the treatment of autoimmune hepatitis in children and adolescents. J Pediatr. (Among 46 children with newly diagnosed autoimmune hepatitis treated with budesonide [6 or 9 mg daily] or prednisolone [40 mg daily initially], complete response rates were similar in the two groups [16% vs 15%], although the decrease in serum ALT levels was faster with prednisolone; no mention of exacerbations or flares of hepatitis with treatment).
Mieli-Vergani G, Vergani D. (2013). Budesonide for juvenile autoimmune hepatitis? Not yet. J Pediatr. (Commentary on Woynarowsk et al. [2013] questioning the role of budesonide in pediatric autoimmune hepatitis, which tends to be more severe than in adults and in whom rapid control of the disease is desirable).
Iborra M, Alvarez-Sotomayor D, Nos P. (2014). Long-term safety and efficacy of budesonide in the treatment of ulcerative colitis. Clin Exp Gastroenterol. (Review of the efficacy and safety of oral budesonide in ulcerative colitis; does not mention serum enzyme elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to budesonide or methylprednisone or other corticosteroids).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to high dose methylprednisolone, but none to budesonide or other corticosteroids).
Rubin DT, Sandborn WJ, Bosworth B, Zakko S, Gordon GL, Sale ME, Rolleri RL, et al. (2015). Budesonide foam has a favorable safety profile for inducing remission in mild-to-moderate ulcerative proctitis or proctosigmoiditis. Dig Dis Sci. (Summary of 5 clinical trials of budesonide rectal foam for ulcerative proctitis found that side effects were similar between budesonide and placebo therapy and there was no evidence of pituitary-adrenal suppression, indicating a low systemic exposure to corticosteroids).
Sherlock ME, MacDonald JK, Griffiths AM, Steinhart AH, Seow CH. (2015). Oral budesonide for induction of remission in ulcerative colitis. Cochrane Database Syst Rev. (Systematic review of the literature concluded that budesonide with or without mesalamine is superior to placebo in inducing remission in ulcerative colitis, and that it is less likely to cause adrenal suppression and side effects than adequate amounts of conventional corticosteroids).
Lichtenstein GR, Travis S, Danese S, D'Haens G, Moro L, Jones R, Huang M, et al. (2015). Budesonide MMX for the induction of remission of mild to moderate ulcerative colitis: a pooled safety analysis. J Crohns Colitis. (Among 835 patients with ulcerative colitis enrolled in 3 controlled trials of budesonide [9, 6 or 3 mg] or placebo daily for 8 weeks, serious adverse events were similar in all groups [2.0-2.7%] as were glucocorticoid related events).
D'Haens G. (2016). Systematic review: second-generation vs. conventional corticosteroids for induction of remission in ulcerative colitis. Aliment Pharmacol Ther. (In a systematic review of 21 studies of conventional corticosteroids vs those that target the site of inflammation of ulcerative colitis [small intestine and colon], budesonide and beclomethasone were judged to be superior to placebo and similar to conventional corticosteroids, but with “a more favorable safety and tolerability profile”).
Lipson DA, Barnhart F, Brealey N, Brooks J, Criner GJ, Day NC, Dransfield MT, et al. (2018). IMPACT Investigators. Once-daily single-inhaler triple versus dual therapy in patients with COPD. N Engl J Med. (Among 10355 patients with COPD treated with inhaled glucocorticoids [CS: fluticasone], a long acting muscarinic antagonist [LAMA: umeclidinium] and a long-acting beta-2 agonist [LABA: vilanterol], triple therapy was associated with lower rates of moderate and severe exacerbations than dual therapy, although episodes of pneumonia were more frequent; no mention of ALT elevations or hepatotoxicity in extended analyses of adverse events).
(2018). Trelegy Ellipta--a three-drug inhaler for COPD. Med Lett Drugs Ther. (Concise summary of mechanism of action, clinical efficacy, safety and costs of a three-drug inhaler approved for use in COPD that includes a CS, LAMA and LABA, mentions that inclusion of corticosteroids yielded higher rates of clinical response but higher rates of pneumonia; no mention of ALT elevations or hepatotoxicity).
(2019). OTC drugs for seasonal allergies. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of over-the-counter drugs used to treat seasonal allergies such as allergic rhinitis, includes discussion of intranasal corticosteroids, considered the most effective agents for seasonal allergies, side effects of which can include irritation, dryness, burning and bleeding of nasal mucosa as well as sore throat and headache; no mention of ALT elevations or hepatotoxicity).
Prado NMBL, Messias GC, Santos GO, Nunes VS, Schinonni MI, Paraná R. (2019). Prospective monitoring of drug use: drug-induced liver injury in a primary healthcare center. Arq Gastroenterol. (Among 149 patients followed in a primary care center in Brazil, three were suspected to have developed liver injury due to a medication including nimesulide, budesonide and valacyclovir marked by moderate elevations in ALT levels [176-182 U/L], normal Alk P [46-52 U/L], normal bilirubin [0.3-0.4 mg/dL] and no symptoms, resolving rapidly on drug discontinuation).
Rabe KF, Martinez FJ, Ferguson GT, Wang C, Singh D, Wedzicha JA, Trivedi R, et al. (2020). ETHOS Investigators. Triple inhaled therapy at two glucocorticoid doses in moderate-to-very-severe COPD. N Engl J Med. (Among 8529 patients with COPD treated with inhalants with or without budesonide, moderate or severe exacerbations of COPD were less frequent with budesonide inhalants while episodes of pneumonia were more frequent [3.5% to 4.5% vs 2.3%], and there were no significant changes in clinical laboratory test results).
Bari K, Shah SA, Kaiser TE, Cohen RM, Anwar N, Kleesattel D, Sherman KE. (2020). Safety and efficacy of budesonide for liver transplant immune suppression: results of a pilot phase 2a trial. Liver Transpl. (Among 20 patients undergoing liver transplantation treated postoperatively with budesonide in tapering doses for 12 weeks compared to 20 matched controls treated with tapering doses of prednisone, rates of acute cellular rejection were similar [5% vs 5%] while budesonide was associated with lower rates of new-onset diabetes [0% vs 15%] and opportunistic infections [0% vs 30%]; no mention of ALT elevations or hepatotoxicity).
Drugs for COPD. (2020). Med Lett Drugs Ther. (Concise review of drugs used for COPD including budesonide and systemic corticosteroids indicates that they should not be used as monotherapy but rather as an add on in patients not responding to standard therapy [LABA and/or LAMA], particularly if eosinophils are greater than 300/µL; no mention of adverse events or ALT elevations or hepatotoxicity).
Hirschfield GM, Beuers U, Kupcinskas L, Ott P, Bergquist A, Färkkilä M, Manns MP, et al. (2020). A placebo-controlled randomised trial of budesonide for primary biliary cholangitis following an insufficient response to UDCA. J Hepatol. (Among 62 patients with primary biliary cirrhosis with an inadequate response to ursodiol who were treated with addition of budesonide vs placebo for 36 months, Alk P and ALT levels improved more with budesonide, but liver histology changes were similar in the two groups and corticosteroid related adverse events [cataracts, weight gain, hypertension, osteopenia] were more frequent with budesonide).

## OTHER REFERENCE LINKS

1 Recent References on Budesonide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Budesonide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Budesonide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Budesonide)